# Pexidartinib

## OVERVIEW

### Introduction

Pexidartinib is an orally available small molecule multi-kinase inhibitor that is used as an antineoplastic agent in the treatment of tenosynovial giant cell tumors. Pexidartinib is associated with a high rates of serum aminotransferase and alkaline phosphatase elevations during therapy and has been implicated in several cases of clinically apparent liver injury marked by progressive intrahepatic bile duct injury, some of which resulted in liver transplantation or were fatal.

### Background

Pexidartinib (pex” i dar’ ti nib) is a potent small molecule inhibitor of several kinase receptors, including colony stimulating factor 1 (CSF1) receptor, FMS-like tyrosine kinase 3 receptor (FLT3) and the proto-oncogene c-kit. These kinase receptors activate intracellular signaling cascades that can promote unregulated cell growth and proliferation. Tenosynovial giant cell tumors (TGCT) are rare, locally aggressive malignancies for which there are no known effective therapies other than surgery. Genetic analyses of the malignant cells in TGCT show a frequent translocation between chromosome 1 (1p13) and 2 (2q35) leading to a mutated CSF1 and its overexpression. In vivo and in vitro studies show that inhibition of the CSF1 receptor leads to inhibition of tumor cell growth and, in clinical trials, pexidartinib was found to induce objective responses in a proportion of patients with symptomatic, advanced TGCTs. Pexidartinib received accelerated approval for this indication in the United States in 2019 and is available in capsules of 200 mg under the brand name Turalio. The recommended dose is 400 mg twice daily, continued until progressive disease or intolerable toxicity occurs. Side effects are common and can include change in hair color, fatigue, nausea, myalgia, arthralgia, diarrhea, abdominal pain, headache and peripheral, facial and periorbital edema. Uncommon, but potentially severe side effects include hepatotoxicity and embryo-fetal toxicity. Largely because of hepatotoxicity, pexidartinib is available only through a restricted FDA Risk Evaluation and Mitigation Strategy (REMS) Program.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during pexidartinib therapy, occurring in 50% to 90% of patients and rising above 5 times the upper limit of the normal range in 12% to 20%. In addition, elevations in alkaline phosphatase levels occur in up to 20% of treated persons. In registration trials, clinically apparent liver injury with jaundice developed in 5% of patients. The time to onset of liver injury was typically between 2 and 6 weeks, and the pattern of liver enzyme elevations was mixed or cholestatic. Autoimmune and immune-allergic features were not prominent. Liver biopsy demonstrated bile duct injury and loss, and at least 3 patients in studies for conditions other than TGCT developed bile duct paucity and features of vanishing bile duct syndrome that ultimately led to liver transplantation in one subject. Pexidartinib has had limited clinical use and the frequency and spectrum of acute liver injury with its use is not yet well defined.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the cholestatic liver injury due to pexidartinib is not known. Pexidartinib is metabolized in the liver largely by the cytochrome P450 system (largely CYP 3A4) and is susceptible to drug-drug interactions with inhibitors or inducers of the microsomal CYPs.

### Outcome and Management

Pexidartinib therapy has been associated with transient serum aminotransferase elevations during therapy in at least half of subjects and with several instances of acute liver injury with jaundice and symptoms. Severe progressive cholestasis leading to liver transplantation or death has been described in several patients receiving pexidartinib for which reason it is available only through a restricted REMS Program, which mandates monitoring of liver tests before and during therapy and avoidance of taking other hepatotoxic agents or drugs that might lead to drug-drug interactions. Specific instructions on dose modification as well as temporary and permanent discontinuation for adverse reactions are available from the product label for pexidartinib, a link to which is provided below.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pexidartinib – Turalio®

DRUG CLASS

Antineoplastic Agents

[underlined: COMPLETE LABELING] (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=24c5a6f1-b640-4d14-b44b-dd293ed002b1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pexidartinib | 1029044-16-3 (https://pubchem.ncbi.nlm.nih.gov/substance/249748716) | C20-H15-Cl-F3-N5

## ANNOTATED BIBLIOGRAPHY

References updated: 01 October 2019

Abbreviations: CSF-1, colony stimulating factor-1; FLT3, FMS-like tyrosine kinase-3; TGCT, tenosynovial giant cell tumor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of pexidartinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm?event=overview.process&varApplNo=211810 (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; in the “Other Reviews” section on pexidartinib, liver injury is discussed in detail. In the controlled trial of pexidartinib, 66% patients developed ALT elevations on treatment and 5 subjects had severe hepatotoxicity which was typically cholestatic or mixed in pattern and was associated with loss of bile ducts and prolonged jaundice; other trials of pexidartinib noted a similar rate and pattern of hepatotoxicity including 2 further cases of vanishing bile duct syndrome, yielding total of 12 probable cases of clinically apparent hepatotoxicity).
Tap WD, Wainberg ZA, Anthony SP, Ibrahim PN, Zhang C, Healey JH, Chmielowski B, et al. (2015). Structure-guided blockade of CSF1R kinase in tenosynovial giant-cell tumor. N Engl J Med. (Among 43 patients with advanced TGCT treated with pexidartinib in a dose-finding and extension study, 52% had an objective response, but side effects were common including ALT or AST elevations; in the extension study 61% had dose reductions and 30% temporary discontinuations).
Giustini N, Bernthal NM, Bukata SV, Singh AS. (2018). Tenosynovial giant cell tumor: case report of a patient effectively treated with pexidartinib (PLX3397) and review of the literature. Clin Sarcoma Res. (47 year old woman with symptomatic TGCT had an objective response within months of starting pexidartinib and had stable disease on therapy for 55 months; no mention of abnormal liver test results).
Piawah S, Hyland C, Umetsu SE, Esserman LJ, Rugo HS, Chien AJ. (2019). A case report of vanishing bile duct syndrome after exposure to pexidartinib (PLX3397) and paclitaxel. NPJ Breast Cancer. (62 year old woman with ER-positive, HER2-negative breast cancer developed fever 3 weeks after starting therapy with paclitaxel and pexidartinib who developed liver injury after admission; antibiotic therapy was started, followed by cholecystectomy [bilirubin 10.9 mg/dL, ALT 194 U/L, Alk P 377 U/L], liver biopsy showing a cholestatic hepatitis with bile duct loss and subsequent course marked by persistent pruritus, jaundice and cholestasis, ultimately undergoing successful liver transplant, the explant showing cirrhosis and ductopenia).
Tap WD, Gelderblom H, Palmerini E, Desai J, Bauer S, Blay JY, Alcindor T, et al., ENLIVEN investigators. (2019). Pexidartinib versus placebo for advanced tenosynovial giant cell tumour (ENLIVEN): a randomised phase 3 trial. Lancet. (Among 120 adults with symptomatic, advanced TGCT enrolled in a randomized controlled trial, response rates were seen in 24 of 61 pexidartinib [39%] but none of 59 placebo recipients, while side effects were common including change in hair color [67% vs 3%], fatigue [54% vs 36%], nausea [38% vs 41%], peripheral edema [13% vs 2%], facial edema [13% vs 2%] and ALT elevations [28% vs 1%] which were above 5 times ULN in 10% vs none, while 3 patients developed liver injury with jaundice which was often prolonged and led to apparent bile duct paucity in one subject).
Lee JH, Chen TW, Hsu CH, Yen YH, Yang JC, Cheng AL, Sasaki SI, et al. (2019). A phase I study of pexidartinib, a colony-stimulating factor 1 receptor inhibitor, in Asian patients with advanced solid tumors. Invest New Drugs. (Among 11 Asian patients with various symptomatic, advanced solid tumors treated with pexidartinib, the only patient with an objective response had a TGCT; side effects included ALT or AST elevations above 3 times ULN in 36% and bilirubin elevations in 18%).

## OTHER REFERENCE LINKS

1 [underlined: Recent References on Pexidartinib] (https://www.ncbi.nlm.nih.gov/pubmed/?term=Pexidartinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI)+AND+(%221900%2F1%2F1%22%5BEDat%5D%3A%222999%2F12%2F31%22%5BEDat%5D)) [underlined: : from PubMed.gov]
2 [underlined: Trials on Pexidartinib] (https://clinicaltrials.gov/ct2/results?term=Pexidartinib) [underlined: : from ClinicalTrials.gov]